# Hyoscyamine

## OVERVIEW

### Introduction

Hyoscyamine as a natural plant alkaloid derivative and anticholinergic that is used to treat mild to moderate nausea, motion sickness, hyperactive bladder and allergic rhinitis. Hyoscyamine has not been implicated in causing liver enzyme elevations or clinically apparent acute liver injury.

### Background

Hyoscyamine (hye" oh sye' a meen) is a derivative of natural alkaloid found in plants of the Solanacea family such as henbane (Hyoscyamus niger, for which it is named), jimson weed (Datura stramonium), tomatoes (Soanum lycopersicum) and deadly nightshade (Atropa belladonna). Hyoscyamine is the levorotary isomer of atropine and has potent anticholinergic, antimuscarinic activity. It has been used for decades as an antiemetic, antisecretory and antispasmotic agent in the treatment of nausea, motion sickness, allergic rhinitis, gastrointestinal spasm and hypermotility, functional bowel syndrome and hyperactive bladder. Despite having been used in clinical medicine for decades, hyoscyamine has not been formally approved for many of its common uses in the United States. Hyoscyamine is available as tablets, capsules, liquids, elixirs, powders, and solutions for injection in both prescription and over-the-counter forms. Common brand names for products that include hyoscyamine are Belladonna Alkaloids, Donnatal, Hyomax, Urogesic, and Cyclospaz. The recommended adult oral dose varies, but is generally 0.125 to 0.25 mg two to four times daily. Common side effects are those of parasympathetic stimulation and include dryness of the mouth and eyes, decreased sweating, headache, visual blurring, constipation, urinary retention, impotence, tachycardia and palpitations, anxiety, restlessness and in some instances agitation and hallucinations. Anticholinergic agents can precipitate acute narrow angle glaucoma and acute urinary retention.

### Hepatotoxicity

Despite widespread use over many decades, hyoscyamine has not been linked to episodes of liver enzyme elevations or clinically apparent liver injury. A major reason for its safety may relate to the low daily dose and limited duration of use.

References on the safety and potential hepatotoxicity of anticholinergics are given together after the Overview section on Anticholinergic Agents.

Drug Class: Gastrointestinal Agents; Anticholinergic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Hyoscyamine – Generic, Anaspaz®

DRUG CLASS

Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Hyoscyamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Hyoscyamine | 101-31-5 | C17-H23-N-O3 | Hyoscyamine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Hyoscyamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Hyoscyamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Hyoscyamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Hyoscyamine)